# Chronic Hepatitis

Description. The course of illness resembles chronic viral hepatitis with serum aminotransferase elevations without jaundice and with mild if any symptoms. Serum aminotransferase levels may fluctuate over time and intermittently fall into the normal range.

Latency to Onset. The first onset of aminotransferase elevations may be within weeks or months of starting the medication, but the diagnosis of chronic hepatitis requires that elevations are present for several months or a liver biopsy showing typical features of chronic hepatitis. Sometimes the duration of the elevations is not known, but biochemical and clinical characteristics suggest chronic injury.

Symptoms. Usually minimal if present at all and include nonspecific symptoms of weakness, fatigue, intermittent nausea and abdominal discomfort.

Serum Enzyme Elevations. A hepatocellular pattern of serum enzyme elevations with ALT that persists in being above the ULN, with some values at least 2 times ULN over a period of at least 6 months. Alkaline phosphatase and serum bilirubin may be mildly elevated, but are rarely >2 times ULN. Autoantibodies are common particularly if the injury is severe.

Drugs. Medications that can cause a chronic hepatitis include isoniazid, propylthiouracil, nitrofurantoin, minocylcine, fibrates, statins, hydralazine and methyldopa. These medications can also cause acute hepatitis or an autoimmune hepatitis like syndrome, so that chronic hepatitis due to medications may be a mild form of acute drug induced hepatitis in which the medication is continued so that the injury becomes chronic. Drug induced chronic hepatitis usually occurs in patients while on a medication chronically. The persistence of chronic hepatitis after stopping a medication is very uncommon and probably represents an unrelated process or autoimmune hepatitis triggered by the medication.

Differential Diagnosis. Other causes of chronic hepatitis include autoimmune hepatitis and hepatitis B, C and D and hepatitis E (due to genotype 3 HEV and usually in immunosuppressed patients). Clinical features of chronic hepatitis can also accompany celiac disease and inflammatory bowel disease. Nonalcoholic and alcoholic liver disease can cause serum aminotransferase elevations typical of chronic hepatitis, but imaging of the liver and liver biopsy demonstrate steatosis and a different pattern of liver injury (zone 3 ballooning degeneration).

Criteria for Definition. Elements important in the diagnosis are exclusion of other causes (hepatitis A, B, C and E) and features of chronic hepatitis as shown by:

1 Persistent ALT levels above the ULN on at least 3 occasions
2 Alkaline phosphatase levels of less than 2 times ULN
3 Minimal and nonspecific symptoms
4 Mild or minimal bilirubin elevations
5 Liver biopsy changes of chronic hepatitis with portal inflammation and spotty lobular inflammation and necrosis with variable decrees of interface hepatitis and portal fibrosis.

It is often difficult to distinguish between a mild, anicteric case of drug induced acute hepatitis and drug induced chronic hepatitis, but the time to onset and insidious nature of the presentation can help to distinguish the two. The mild, transient ALT elevations that occur with many medications are usually benign and nonprogressive, and can resolve even with continuation of the drug. In contrast, the ALT elevations that occur with chronic hepatitis induced by medications usually indicate significant liver injury that can lead to fibrosis and even cirrhosis. The importance of making this distinction is important both for differential diagnosis and management. The differential diagnosis of chronic hepatitis includes idiopathic autoimmune hepatitis which can present an identical fashion. The management is to discontinue the medication, but corticosteroid therapy may be appropriate if the hepatitis is slow to resolve or severe.

## Representative Cases

### Case 1. Chronic hepatitis due to nitrofurantoin.

[DILIN Case: 104-0025]

A 68 year old woman was given nitrofurantoin (50 mg daily) for prophylaxis against recurrent urinary tract infections. She continued on therapy for 3 years at which time serum enzymes were found to be elevated. She had no symptoms that could be attributed to liver disease. Nitrofurantoin was stopped, but restarted one month later because of recurrence of urinary tract infections. Serum aminotransferase levels remained mildly elevated (2 to 3 times the upper limit of normal). Six months later, she had the insidious onset of nausea, fatigue and weakness. Serum aminotransferase levels were still elevated, but alkaline phosphatase and bilirubin values were normal. Anti-smooth muscle antibody was present (1:80), but other autoantibodies were not detected. Tests for hepatitis A, B and C were negative. A liver biopsy showed chronic active hepatitis with moderate to severe inflammatory infiltrates and moderate fibrosis. The symptoms persisted for several months and the medication was discontinued again. Two months after stopping nitrofurantoin, the patient had returned to her usual state of health and serum aminotransferase levels returned to normal.

#### Key Points

Medication: | Nitrofurantoin, 50 mg daily
Pattern: | Hepatocellular (aminotransferase elevations only)
Severity: | 1+ (never jaundiced, never hospitalized)
Latency: | Several years, 6 months after restarting
Recovery: | Complete within 5 months
Other medications: | Sumatriptan, alendronate, clopidrogel, estrogen, verapamil

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Nitrofurantoin started
1 month | | 79 | 62 | 0.4
3 months | | 115
4 months | | 88 | | | Nausea, fatigue
5 months | | 255 | | | Liver biopsy
6 months | 0 | 176 | 99 | 0.5 | Smooth muscle antibody positive
Nitrofurantoin stopped
9 months | 3 months | 52 | 101 | 0.7
1 year | 5 months | 30 | 102 | 0.7
Normal Values | | <42 | <115 | <1.2

#### Comment

Initially, the liver injury was believed to be caused by chronic hepatitis unrelated to medications. Because of appearance of symptoms and findings on liver biopsy, nitrofurantoin was subsequently suspected and discontinued. The resolution of liver test abnormalities and symptoms of fatigue after stopping nitrofurantoin supported the diagnosis of drug induced liver disease. While the clinical pattern resembles chronic hepatitis, the disease generally resolves when the medication is stopped. However, long term follow up to document resolution of hepatitis is warranted.

### Case 2. Chronic hepatitis-like syndrome caused by long term methyldopa therapy.

[DILIN Case: 104-0034]

A 25 year old woman developed signs and symptoms of chronic liver disease after 8 months of therapy with methyldopa. Methyldopa had been started in a dose of 250 mg twice daily during a pregnancy, but was then continued after she had a Caesarian section 3 months later. After being on methyldopa for 8 months, she had the insidious onset of nausea, dark urine, itching and jaundice. She was admitted to a local hospital and laboratory testing showed an ALT of 1292 U/L and bilirubin of 7.3 mg/dL. Tests for hepatitis A, B and C were negative. Both smooth muscle and antinuclear antibody were negative. CT scans and ultrasound of the liver were normal. A liver biopsy showed changes typical of chronic active hepatitis. Methyldopa was stopped, and she was placed on prednisone. Serum aminotransferases slowly improved. Six months later prednisone was stopped and in follow up her liver tests remained normal.

#### Key Points

Medication: | Methyldopa
Pattern: | Hepatocellular (R=21)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 8 months
Recovery: | Complete after 6 month course of prednisone
Other medications: | Triamterene

#### Laboratory Values

Months After Starting | Weeks After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Methyldopa started during pregnancy
8 | 0 | 1292 | 126 | 10.3 | Methyldopa stopped
8 | 1 | 1053 | 101 | 19.3
9 | 2 | 1140 | 156 | 24.9 | Prednisone started
9 | 4 | 362 | 169 | 11.9
10 | 6 | 88 | 102 | 3.0
10 | 8 | 64 | 113 | 2.0
11 | 12 | 80 | 61 | 1.0 | Prednisone tapered
12 | 16 | 45 | 74 | 1.0
14 | 24 | 29 | 69 | 0.5 | Prednisone stopped
20 | 52 | 19 | 83 | 1.0
Normal Values | | <60 | <126 | <1.2

#### Comment

This case represents a moderately severe example of chronic hepatitis induced by methyldopa. Initially, the clinical features suggested an acute drug induced liver injury, but the course and liver biopsy indicated a chronic process. The use of prednisone is controversial, but the height of the bilirubin and ALT elevation led to its use. Importantly, once methyldopa was stopped, the prednisone was withdrawn gradually, and in follow up, this patient was asymptomatic and had normal liver tests.

### Case 3. Asymptomatic chronic hepatitis during long term diclofenac therapy.

[DILIN 102-0031]

A woman in her early 40s with a history of chronic knee pain was treated with diclofenac in a dose of 50 mg thrice daily. She complained of a new onset of sharp, intermittent right upper quadrant pain and itching of the lower extremities and was found to have elevated serum aminotransferase levels on routine lab work approximately 5 months after starting diclofenac. She denied fever, nausea, weight loss or jaundice. Tests for hepatitis A, B and C were negative, but antinuclear antibodies were strongly positive. A liver biopsy was consistent with chronic hepatitis of moderate to severe activity with mild periportal fibrosis. The patient was also taking atorvastatin which was discontinued on the basis of its possible role in causing the aminotransferase elevations. Despite this, ALT levels remained elevated. Subsequently, diclofenac was discontinued and both aminotransferase elevations and her abdominal pain resolved promptly.

#### Key Points

Medication: | Diclofenac
Pattern: | Hepatocellular (R=8)
Severity: | 1+ (never jaundiced, never hospitalized)
Latency: | 5 months
Recovery: | Complete recovery within 3 months
Other medications: | Atorvastatin, ibuprofen, fexofenadine, rabeprazole, propranolol, synthroid, triamterene, hydrochlorothiazide, sumatriptan, glucosamine, chondroitin

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | | | | Diclofenac started
5 months | | 332 | 126 | 0.5 | Itching, RUQ pain
7.5 months | | 68 | 110 | 0.4
9 months | | 430 | | | Biopsy, atorvastatin stopped
16 months | 0 | 250 | 119 | 0.5 | Diclofenac stopped
19 months | 3 months | 29 | 93 | 0.7
Normal Values | | <42 | <115 | <1.2

#### Comment

The association of serum aminotransferase elevations and diclofenac is supported by the resolution of the abnormalities once the medication was stopped. The nonspecific symptoms, presence of antinuclear antibody and fibrosis found on liver biopsy indicate that the injury was chronic rather than acute and argue strongly for stopping diclofenac. The presence of autoantibodies is common with drug induced liver injury and particularly with chronic injury. The resolution of disease upon stopping the medication is usually followed (more slowly) but disappearance of the autoantibodies.

## Histology of Drug Induced Chronic Hepatitis

[Under Construction]